# Amifampridine

## OVERVIEW

### Introduction

Amifampridine is an orally available potassium channel blocker that increases acetylcholine in synaptic clefts of peripheral nerve endings and is used to treat the Lambert-Eaton myasthenic syndrome. Amifampridine is associated with a low rate of transient serum enzyme elevations during therapy but has not been linked with instances of clinically apparent acute liver injury.

### Background

Amifampridine (am" i fam' pri deen) is a diaminopyridine that acts on peripheral potassium channels and is used to treat the Lambert-Eaton myasthenic syndrome, a rare form of myasthenia suspected to be autoimmune in nature. The inhibition of the potassium channel on neuromuscular junctions causes depolarization of the presynaptic membrane resulting in prolonged action potentials and increased release of acetylcholine in the synaptic cleft. This increase in acetylcholine alleviates some of the neuromuscular dysfunction of myasthenia which is caused by defects in acetylcholine signaling. In small open-label and randomized controlled trials, amifampridine was found to alleviate the myasthenic symptoms in patients with the rare Lambert-Eaton myasthenic syndrome, but did not reverse the condition or its associated autoimmunity. In 2018, amifampridine was approved as symptomatic therapy for Lambert-Eaton syndrome in adults and is available in scored tablets of 10 mg under the brand name Firdapse. In 2019, amifampridine was approved as symptomatic therapy for Lambert-Eaton syndrome in children and became available as scored 10 mg tablets under the brand name Fuzurgi. The recommended starting dose is 15 to 30 mg in 3 to 4 divided doses daily with dose increases of 5 mg and a maximum total dose of 80 mg daily. A reduced dose is recommended for children weighing less than 45 kilograms. Common side effects are paresthesia, upper respiratory symptoms, abdominal pain, nausea, diarrhea, headache, back pain, hypertension and muscle spasm. Rare, but potentially serious adverse events include seizures and hypersensitivity reactions.

### Hepatotoxicity

Amifampridine has had limited clinical use, but adverse events have been largely neurologic and gastrointestinal. Serum ALT elevations were not reported in the prelicensure studies of amifampridine but were reported as occurring in a small proportion of patients in safety reviews by the Food and Drug Administration. Nevertheless, there have been no reports of clinically apparent liver injury associated with its use. Thus, liver injury from amifampridine must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but experience with its use is limited).

### Mechanism of Injury

The mechanism by which amifampridine might cause liver injury is not known. It is extensively metabolized by the liver largely by N-acetyltransferase (NAT) to an inactive metabolite. The NAT gene is highly polymorphic and activity rates range from slow to fast. Persons who are slow acetylators have 3- to 5-fold higher plasma levels than those who are fast acetylators. Nevertheless, there is no clinical evidence that acetylation status affects the efficacy or safety of amifampridine to a major extent.

Drug Class: Myasthenia Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amifampridine – Generic, Firdapse®, Ruzurgi®

DRUG CLASS

Myasthenia Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amifampridine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amifampridine | 54-96-6 | C5-H7-N3

## ANNOTATED BIBLIOGRAPHY

References updated: 15 May 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, before the availability of amifampridine, does not discuss myasthenic syndromes and their therapy).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook of hepatotoxicity published in 2013, does not discuss amifampridine or other drugs for myasthenic syndromes).
Taylor P. Anticholinesterase Agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 163-75. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that safety data were based upon 2 controlled withdrawal studies in 79 adults and that elevated liver enzymes occurred in 7 patients [13%], but all were self-limited and not accompanied by symptoms or jaundice).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to drugs used for myasthenic syndromes such as amifampridine).
Verma S, Mazell SN, Shah DA. (2016). Amifampridine phosphate in congenital myasthenic syndrome. Muscle Nerve. (Two children [ages 4 and 5 years] with congenital myasthenic syndromes associated with mutations in the acetylcholine receptor had improvements in clinical symptoms [ptosis, dysarthria, energy level] with amifampridine treatment [10-20 mg daily], with only minor side effects; no mention of ALT levels or hepatotoxicity).
Burns TM, Smith GA, Allen JA, Amato AA, Arnold WD, Barohn R, Benatar M, et al. (2016). Editorial by concerned physicians: Unintended effect of the orphan drug act on the potential cost of 3,4-diaminopyridine. Muscle Nerve. (Commentary by academic neurologists concerned about the approval of amifampridine [3,4-diaminopyridine] as an orphan drug for Lambert-Eaton myasthenic syndrome and the possible result of a very expensive therapy that would replace the reasonably priced compassionate use product).
McEnany PJ. (2017). A response to a recent editorial by concerned physicians on 3,4-diaminopyridine. Muscle Nerve. (Response to the commentary by Burns [2016] argues that the benefit of an FDA approved therapy for Lambert-Eaton syndrome far outweighs the possible negative effect of increase price).
Schoser B, Eymard B, Datt J, Mantegazza R. (2017). Lambert-Eaton myasthenic syndrome (LEMS): a rare autoimmune presynaptic disorder often associated with cancer. J Neurol. (Review of the history of discovery, epidemiology, pathophysiology, clinical features, electromyographic findings, autoimmune serology, diagnosis, management and therapy of Lambert-Eaton myasthenic syndrome; mentions that amifampridine may be effective for its symptomatic treatment [increasing neurotransmission] but that immunosuppressive therapy is needed to decrease disease progression).
Sanders DB, Juel VC, Harati Y, Smith AG, Peltier AC, Marburger T, Lou JS, et al., Dapper Study Team. (2018). 3,4-diaminopyridine base effectively treats the weakness of Lambert-Eaton myasthenia. Muscle Nerve. (Among 32 adults with Lambert-Eaton myasthenia on compassionate use 3,4-diaminopyridine who were either continued on treatment or switched to placebo for at least 3 months, objective measurements of myasthenic symptoms worsened in those who were withdrawn and not in those who continued on therapy, and “there were no clinically meaningful laboratory value changes”).
Bonanno S, Pasanisi MB, Frangiamore R, Maggi L, Antozzi C, Andreetta F, Campanella A, et al. (2018). Amifampridine phosphate in the treatment of muscle-specific kinase myasthenia gravis: a phase IIb, randomized, double-blind, placebo-controlled, double crossover study. SAGE Open Med. (Among 10 patients with muscle-specific kinase myasthenia gravis who were treated with amifampridine or placebo in a double-cross over study, myasthenia symptoms improved on amifampridine and deteriorated on placebo, and the only drug-specific adverse event was transient paresthesia; there were “no relevant differences between the two groups for…blood chemistries…over the duration of the study”).

## OTHER REFERENCE LINKS

1 Recent References on Amifampridine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Amifampridine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Amifampridine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amifampridine)